# Tazemetostat

## OVERVIEW

### Introduction

Tazemetostat is a methyltransferase inhibitor and antineoplastic agent used in the therapy of advanced epithelioid sarcoma. Tazemetostat is associated with a moderate rate of transient serum enzyme elevations during therapy, but has not been implicated in cases of clinically apparent acute liver injury with jaundice.

### Background

Tazemetostat (taz’ met o stat) is a small molecule inhibitor of the histone methyltransferase, enhancer of zest homolog 2 (EZH2), an enzyme that can be overexpressed as a result of gene mutations in certain cancers. In early clinical studies tazemetostat was found to have activity in vitro and in vivo against epithelioid sarcoma, a rare malignant soft tissue sarcoma that has a poor prognosis and is often resistant to other antineoplastic agents. In preregistration open-label trials, tazemetostat therapy was associated with an objective response rate of only 13%. Nevertheless, tazemetostat was given accelerated approval in the United States in 2020 as therapy of adults and children (16 years of age or older) with metastatic or advanced unresectable epithelioid sarcoma. Confirmatory trials were required for its continued approval, and subsequently higher rates of response have been reported in treatment of patients with epithelioid sarcoma as well as other tumors with confirmed mutations in EZH2 or in its pathway of activation. Tazemetostat is available in tablets of 200 mg under the brand name Tazverik. The recommended dose is 800 mg (4 tablets) twice daily in 28-day cycles until unacceptable toxicity or disease progression. Adverse events are common and can include pain, fatigue, nausea, vomiting, constipation, diarrhea, decreased appetite, weight loss, anemia, lymphopenia, alopecia, cough, dyspnea, and headache. Rare but potentially severe adverse events include secondary malignancies including lymphoma, leukemia and myelodysplastic syndromes, and embryo-fetal toxicity.

### Hepatotoxicity

In clinical trials, serum ALT elevations occurred in 14% and AST elevations in 18% of patients on tazemetostat therapy and rose to more than 5 times ULN in 3.5%. Nevertheless, there were no instances of clinically apparent liver injury with symptoms or jaundice in several multicenter open-label trials of tazemetostat. Despite the frequency of adverse events during tazemetostat therapy, discontinuations due to adverse events are uncommon. Clinical experience with tazemetostat, however, is limited and the frequency of de novo serum enzyme elevations during treatment raises the issue of its potential for causing hepatotoxicity.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

Tazemetostat is metabolized in the liver, largely via CYP 3A4 and is likely to be susceptible to drug-drug interactions with moderate or strong inducers or inhibitors of CYP 3A4 which should be avoided during therapy. The cause of the serum aminotransferase elevations during tazemetostat therapy is unknown but may relate to the inhibition of EZH2 methyltransferase or to the production of a toxic or immunogenic metabolite.

### Outcome and Management

The serum enzyme elevations during tazemetostat therapy are mostly mild-to-moderate in severity but elevations above 5 times the ULN should trigger a search for other causes and, if none are found, to use dose modification or transient discontinuation until they fall into the normal or near normal range. Tazemetostat has not been linked to cases of acute liver failure, chronic hepatitis or vanishing bile duct syndrome. There is no information on cross sensitivity to hepatic injury between tazemetostat and other agents used for soft tissue sarcoma such as doxorubicin or pazopanib.

Drug Class: Antineoplastic Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Tazemetostat – Tazverik®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Tazemetostat)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Tazemetostat | 1403254-99-8 | C34-H44-N4-O4

## ANNOTATED BIBLIOGRAPHY

References updated: 04 August 2023

FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2020/211723Orig1s000MultidisciplineR.pdf (FDA website including product label and multidiscipline review of data submitted by the sponsor in support of the approval of tazemetostat, mentions that in a safety cohort of 62 treated subjects ALT elevations arose 14% and were above 5 times the upper limit of normal (ULN) in 3.5% while AST elevations arose in 18% and were above 5 times ULN in 3.5%. Nevertheless, there were no hepatic serious adverse events or deaths from liver failure, and the FDA reviewer concluded that “the overall safety profile of tazemetostat is acceptable for treatment of a serious and life-threatening condition”).
Morschhauser F, Tilly H, Chaidos A, McKay P, Phillips T, Assouline S, Batlevi CL, et al. Tazemetostat for patients with relapsed or refractory follicular lymphoma: an open-label, single-arm, multicentre, phase 2 trial. Lancet Oncol 2020;21:1433-1442. (Among 99 adults with relapsed or refractory follicular lymphoma treated with tazemetostat [800 mg twice daily], the overall objective response rate was 69% in patients with the EZH2 mutant and 35% in those with wild type EZH2, and adverse events were frequent [99%] and were scored as serious in 27%, most frequently nausea, diarrhea, alopecia, cough and fatigue; ALT elevations which were above 5 times ULN arose in one patient but were not associated with symptoms or jaundice and resolved despite continuing therapy; there were no treatment related deaths). 33035457
Gounder M, Schöffski P, Jones RL, Agulnik M, Cote GM, Villalobos VM, Attia S, et al. Tazemetostat in advanced epithelioid sarcoma with loss of INI1/SMARCB1: an international, open-label, phase 2 basket study. Lancet Oncol. 2020;21:1423-1432. (Among 62 patients with advanced epithelioid sarcoma treated with tazemetostat [800 mg twice daily in 28-day cycles until disease progression], 9 [15%] had an objective response with a median follow up of 14 months, and while adverse events were frequent, ALT elevations arose in only 3 patients [5%], treatment related serious adverse events were uncommon [3%], and there were no treatment related deaths). 33035459
Izutsu K, Ando K, Nishikori M, Shibayama H, Teshima T, Kuroda J, Kato K, et al. Phase II study of tazemetostat for relapsed or refractory B-cell non-Hodgkin lymphoma with EZH2 mutation in Japan. Cancer Sci. 2021;112:3627-3635. (Among 20 Japanese patients with relapsed or refractory B-cell lymphoma harboring EZH2 mutations who were treated with tazemetostat, the objective response rate was 80% and complete response rate 50%, and while all patients had at least one adverse event, there were only 3 treatment related serious adverse events, none of which were liver related, and only 2 subjects had ALT elevations, both of which were transient and less than 5 times ULN). 34159682
Zauderer MG, Szlosarek PW, Le Moulec S, Popat S, Taylor P, Planchard D, Scherpereel A, et al. EZH2 inhibitor tazemetostat in patients with relapsed or refractory, BAP1-inactivated malignant pleural mesothelioma: a multicentre, open-label, phase 2 study. Lancet Oncol. 2022;23:758-767. (Among 74 adults with refractory or relapsed malignant pleural mesothelioma and a BAP-1 mutation treated with tazemetostat, the disease control rate at 12 weeks was 54% but there were no complete responses and only one ongoing partial response, and while adverse events were common [99%] and serious adverse events arose in 34%, there was no mention of ALT elevations or treatment related hepatic adverse events). 35588752

## OTHER REFERENCE LINKS

Recent References on Tazemetostat: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Tazemetostat/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Tazemetostat: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Tazemetostat)